# Covid-19 Drugs

## OVERVIEW

In late 2019 a severe outbreak of acute respiratory illness was first identified in Wuhan, China and was shown to be due to a novel coronavirus, the Severe Acute Respiratory Syndrome associated Coronavirus-2 (SARS-CoV-2). The infection rapidly spread globally, causing severe morbidity and mortality worldwide. Within a year of its recognition as a global pandemic, more than 100 million persons had been infected with SARS-CoV-2 and more than 2 million had died of the resulting pneumonia and systemic illness, referred to has COVID-19. Antiviral therapies as well as immunomodulatory treatments evolved quickly, and preventive approaches were attempted, including use of convalescent serum, immune globulins, and monoclonal antibodies. Most importantly, innovative vaccines were developed, several of which have been granted emergency use authorization (EUA) in the United States and abroad. Hepatotoxicity has not been a major problem with most agents used in therapy of COVID-19, but instances of acute liver injury have been reported. Confounding the situation, it is also clear that patients with severe COVID-19 often have liver test abnormalities and some may have significant liver injury seemingly caused by the acute coronavirus infection itself.

The therapy of COVID-19 includes oral and parenterally administered agents, antiviral drugs, immunomodulatory medications, anticytokines, monoclonal antibodies and miscellaneous agents. Many of the agents are conventional medications, initially approved for other medical conditions and repurposed to treat COVID-19. Prevention of COVID-19 was initially attempted using public health measures, as well as pre- and post-exposure antiviral therapies but was ultimately more reliably achieved by vaccination. Vaccines effective in preventing COVID-19 were developed rapidly and approved for use by the FDA in the United States under emergency use authorization. Use of convalescent plasma, immune globulins and monoclonal antibodies have also been assessed as means of prevention with promising but only partial efficacy. Most recently, specific, direct-acting antiviral agents have been developed with potent activity against SARS-CoV-2 in vitro and in vivo. These agents were found to be effective if administered soon after onset of infection, most reliably if given with 5 days of onset of symptoms or first identification of infection.

Hepatotoxicity is rare with most medications used to treat COVID-19, but can occur. Most medications are given for a short time only, and the symptoms and signs of the SARS-CoV-2 infection overshadow the mild and transient liver injury that arises with some of the medications used to treat or manage COVID-19. Furthermore, instances of acute hepatitis and bile duct injury and loss have been reported in patients with severe COVID-19 in which medications did not appear to play a role.

Repurposed drugs that have been applied to treatment of COVID-19 include chloroquine and hydroxychloroquine, azithromycin, ivermectin, fluvoxamine colchicine, interferon beta and lopinavir/ritonavir. Despite early enthusiasm and some in vitro and animal model data supporting use of these agents, none of them has been shown to improve symptoms or signs, shorten the duration of illness, prevent complications or decrease mortality. Most of these agents have been implicated in rare cases of drug induced liver disease, but no specific instances of clinically apparent liver injury have been convincingly shown in case reports, case series or clinical trials of these agents being used as therapy of COVID-19.

Specific antiviral agents for SARS-CoV-2 are still being developed. As of the start of 2022, three direct acting antivirals have received Emergency Use Authorization (EUA) as therapy for COVID-19. All three agents – molnupiravir, nirmatrelvir (Paxlovid) and remdesivir – have potent activity against SARS-CoV-2 in cell culture and in animal models of COVID-19. They are particularly potent when administered early after exposure in ameliorating the subsequent severity of infection. In randomized controlled trials in humans with early COVID-19 who were at high risk for complications, all three agents were found to reduce the rate of subsequent hospitalization and death. While remdesivir requires intravenous administration (once daily for 3 days), molnupiravir and Paxlovid are administered orally (typically twice daily for 5 days). Only remdesivir has received full approval for use in COVID-19 infection, but the indication for this approval was for use in hospitalized patients with severe COVID-19 pneumonia and need for supplementary oxygen. In one large, randomized controlled trial, remdesivir was reported to shorten the time to recovery in hospitalized patients with severe COVID-19 pneumonia needing supplementary oxygen. This effect was not confirmed in other controlled trials, but remdesivir has become the standard of care in patients with life-threatening COVID-19.

Analysis of cytokines and inflammatory pathways during severe COVID-19 pneumonia suggested that robust dysregulated inflammatory responses play a role in disease severity and organ failure. Accordingly, anticytokines have been assessed as adjunctive therapies for the hyperinflammatory features of severe COVID-19 infection. Agents that have shown promising effects for treating COVID-19 infection include IL-6 inhibitors such as sarilumab and tocilizumab and small molecule inhibitors of JAK kinases, including baricitinib and ruxolitinib. Some of these agents have received provisional emergency use authorization. Interestingly, dexamethasone has been assessed in clinical trials and shown convincing evidence of reducing morbidity and mortality in patients with severe COVID-19 pneumonia and respiratory failure. Its usefulness in patients with earlier or less severe pulmonary compromise is not clear, and it is now recommended only for patients requiring high-flow oxygen or mechanical ventilation or in high risk patients with hypoxia requiring supplemental inhaled oxygen.

Several human monoclonal antibodies directed to the receptor binding domain of the spike protein of the SARS-CoV-2 virus have been developed and assessed in patients with COVID-19 infection. EUA has been granted to four such biologic products which are now recommended to be used in combination, namely, bamlanivimab with etesevimab and casirivimab with imdevimab, in nonhospitalized patients with early stages of COVID-19 infection. These monoclonal antibodies have also been used in attempts to prevent SARS-CoV-2 infection after known exposure (postexposure prophylaxis) and appear to be partially effective.

Most trials of therapy of COVID-19 infection employ an ordinal scale to assess clinical status and improvement (Table below). This scale is also used to define sequential phases of the clinical syndrome and to define indications for when to start specific therapies. Whether the patient is at high risk for complications (older age, obesity, diabetes, cardiovascular disease, arterial hypertension, immune suppression, other co-morbidities) is also used to recommend therapy, usually to expand indications. Thus, monoclonal antibodies are recommended for patients in categories 1 and 2, particularly if they are in a high risk group. Remdesivir appears to have its main effects in patients in categories 5 and 6 but is also recommended in patients in category 4 who are at high risk of complications. The combination of remdesivir and baricitinib has been found to have significant benefit largely in patients in categories 5 to 7 and while dexamethasone demonstrated its major effects in patients in categories 6 and 7.

### Table

Ordinal Scale for Grading Disease Severity and Responses to Therapy of COVID-19

1 | Not hospitalized, no limitations on activities
2 | Not hospitalized, limitation on activities and/or requiring home oxygen
3 | Hospitalized, not requiring supplemental oxygen – no longer requires ongoing medical care
4 | Hospitalized, not requiring supplemental oxygen – requiring ongoing medical care
5 | Hospitalized, requiring supplemental oxygen
6 | Hospitalized, on non-invasive ventilation or high flow oxygen devices
7 | Hospitalized, on mechanical ventilation or ECMO
8 | Death

Research on prevention and treatment of SARS-CoV-2 infection is proceeding rapidly and new studies are published weekly making it difficult to provide up-to-date information and recommendations. Data on hepatotoxicity of the agents used to treated COVID-19, however, are sparse, and the hepatic adverse events during therapies are not always well described and not always clearly attributable to a specific medication. The typical patient with severe COVID-19 pneumonia will be receiving a dozen or more medications, a proportion of which are capable of causing hepatotoxicity. Nevertheless, serious hepatic adverse reactions or deaths from hepatic failure are rare except as a part of end-stage, multiorgan failure. Even in patients with preexisting liver disease, fatalities from COVID-19 are usually due to respiratory rather than hepatic failure.

Perhaps most important in control and management of SARS-CoV-2 infection is vaccination, and several highly effective and safe vaccines have been developed and are now being used widely. In the United States, three COVID-19 vaccines have been granted emergency use authorization for use and a fourth may be approved shortly. Other vaccines have been produced in Russia and in China have been found effective in trials in those countries and are now being widely used abroad.

COVID-19 vaccines have not been definitively linked to instances of liver injury, either in the form of serum enzyme elevations or clinically apparent liver injury. Recently, however, two somewhat distinctive syndromes with liver injury have been described. The first syndrome is referred to as vaccine-induced thrombotic thrombocytopenia (VITT) and has been identified in rare subjects (~1 per million overall) receiving adenoviral vector-based vaccines. This syndrome arises 1 to 3 weeks after initial vaccination, most frequently in younger subjects (less than 55 years of age) and in women, and is characterized clinically by thrombotic events in unusual sites (brain and splanchnic venous system) accompanied by thrombocytopenia and antibodies to platelet factor-4. Thrombotic events can include portal vein thrombosis and be associated with liver test abnormalities. The second syndrome is an acute hepatitis arising within 1 to 4 weeks of vaccination (usually the initial dose). Patients present with fatigue, nausea, dark urine and jaundice and laboratory tests generally show features suggestive of acute hepatitis with autoimmune features, such as autoantibodies (ANA, SMA) and elevations in serum immunoglobin levels. Liver histology generally shows a lobular hepatitis and portal inflammation with lymphocytes and plasma cells, features typical of autoimmune hepatitis. Importantly, the liver injury responds promptly to corticosteroid therapy. In most cases, the disease resolves and the corticosteroids can eventually be discontinued without recurrence of injury. The cause of this syndrome remains unknown, and one possibility is that the autoimmune hepatitis is spontaneous, coincidental and unrelated to vaccination.

Background information and discussion of hepatotoxicity of the major agents used to prevent and treat COVID-19 are provided in individual chapters. It is important to stress that LiverTox focuses on the hepatic effects of drugs and biologics and should not be used as guidance for use of these agents, such as for specific indications, drug dosing and regimens.

Important sites with current information on COVID-19, COVID vaccines and treatment guidelines are given below.

NIH Treatment Guidelines on management of COVID-19.

https://www.covid19treatmentguidelines.nih.gov/overview/

European Medicines Agency on management of COVID-19.

https://www.ema.europa.eu/en/human-regulatory/overview/public-health-threats/coronavirus-disease-covid-19/covid-19-latest-updates

FDA Summary on COVID-19 Vaccines.

https://www.fda.gov/emergency-preparedness-and-response/coronavirus-disease-2019-covid-19/covid-19-vaccines

CDC Directives on COVID-19.

https://www.cdc.gov/coronavirus/2019-ncov/index.html

WHO Therapeutics/Vaccines and COVID-19.

https://www.who.int/teams/health-care-readiness/covid-19/therapeutics

https://www.who.int/emergencies/diseases/novel-coronavirus-2019/covid-19-vaccines

The following links are to individual chapters in LiverTox.

- Antiviral Agents
  - Favipiravir, Molnupiravir, Paxlovid, Remdesivir
- Immunomodulatory Agents
  - Janus Kinase (JAK) Inhibitors: Baricitinib, Ruxolitinib, Tofacitinib
  - Monoclonal Antibodies to IL-6: Sarilumab, Tocilizumab
  - Corticosteroids: Cortisol, Dexamethasone, Methylprednisolone
- Monoclonal Antibodies to SARS-CoV-2
  - Bamlanivimab, Casirivimab, Etesevimab, Imdevimab, Sotrovimab
- COVID-19 Vaccines
  - mRNA: BNT162b2 [Pfizer-BioNTech], mRNA-1273 [Moderna]
  - Adenovirus Vector: ChAdOx1-S [AstraZeneca, Oxford]; Ad26.COV2.S [Johnson and Johnson, Janssen], Sputnik-V-Gam – COVID Vac Ad5+Ad26 [Gamleaya]
  - Recombinant Nanoparticles: NVX-CoV2373 [Novavax]
- Miscellaneous Agents
  - Azithromycin, Chloroquine, Dexamethasone, Fluvoxamine, Hydroxychloroquine, Ivermectin

## ANNOTATED SELECTED BIBLIOGRAPHY

References updated: 25 January 2022

Zhu N, Zhang D, Wang W, Li X, Yang B, Song J, Zhao X, et al. (2020). China novel coronavirus investigating and research team. A novel coronavirus from patients with pneumonia in China, 2019. N Engl J Med. (In December 2019, a cluster of patients with severe pneumonia of unknown cause was linked to a seafood wholesale market in Wuhan, China, and was found to be due to a novel coronavirus).
Guan WJ, Ni ZY, Hu Y, Liang WH, Ou CQ, He JX, Liu L, et al., China Medical Treatment Expert Group for COVID-19. (2020). Clinical characteristics of coronavirus disease 2019 in China. N Engl J Med. (Among 1099 patients hospitalized with COVID-19 at 552 hospitals in China through January 2020, the median age was 47 years, 42% were women, 2.4% were admitted to an ICU, 1.4% died and ALT elevations arose in 4.1%).
Cao B, Wang Y, Wen D, Liu W, Wang J, Fan G, Ruan L, et al. (2020). A trial of lopinavir-ritonavir in adults hospitalized with severe Covid-19. N Engl J Med. (Among 199 patients with confirmed COVID-19 pneumonia treated with lopinavir/ritonavir or with standard care, there were differences in mortality rate [19% vs 25%]).
Adams KK, Baker WL, Sobieraj DM. (2020). Myth busters: dietary supplements and COVID-19. Ann Pharmacother. (Review of the evidence on the efficacy and safety of various dietary supplements that are popularly used to prevent or treat symptoms of COVID-19, none of which have been shown to be beneficial).
Boulware DR, Pullen MF, Bangdiwala AS, Pastick KA, Lofgren SM, Okafor EC, Skipper CP, et al. (2020). A randomized trial of hydroxychloroquine as postexposure prophylaxis for COVID-19. N Engl J Med. (Among 821 patients with exposure to COVID-19 treated with oral hydroxychloroquine or placebo for 5 days, rates of new illness compatible with COVID-19 were similar in the two groups [14% vs 12%], while adverse events were more frequent with hydroxychloroquine [40% vs 17%]; ALT elevations were not mentioned).
Beigel JH, Tomashek KM, Dodd LE, Mehta AK, Zingman BS, Kalil AC, Hohmann E, et al., ACTT-1 Study Group Members. (2020). Remdesivir for the treatment of COVID-19 – final report. N Engl J Med. (Final report of a randomized, placebo-controlled trial of remdesivir infusions for 10 days in 1062 adults hospitalized with COVID-19 pneumonia found treatment resulted in more rapid recovery time [10 vs 15 days] and slightly lower mortality at 29 days [11.4% vs 15.2%], while adverse events were less frequent with the active drug including serious adverse events [24% vs 32%], and elevations in serum ALT [2.3% vs 4.7%], AST [3.4% vs 6.4%] and bilirubin [1.7% vs 3.1%]; no mention of clinically apparent liver injury).
Horby P, Lim WS, Emberson JR, Mafham M, Bell JL, Linsell L, et al., RECOVERY Collaborative Group. (2021). Dexamethasone in hospitalized patients with Covid-19. N Engl J Med. (Among 6425 hospitalized patients with COVID 19 enrolled in a large multicenter pragmatic trial, the 28 day mortality was lower among those who received dexamethasone [6 mg daily for up to 10 days] versus those receiving usual care alone [22.9% vs 25.7%], the decrease in mortality being seen in those on mechanical ventilation [29.3% vs 41.4%] or receiving oxygen [23.3% vs 26.2%], but not on those receiving no respiratory support [17.8% vs 14%]; there were no serious hepatic adverse events or deaths from liver injury).
Hundt MA, Deng Y, Ciarleglio MM, Nathanson MH, Lim JK. (2020). Abnormal liver tests in COVID-19: A retrospective observational cohort study of 1827 patients in a major U.S. hospital network. Hepatology. (Among 1877 patients hospitalized with SARS-CoV-2 infection, serum ALT levels were elevated before hospitalization in 19%, at admission in 42% and at peak during hospitalization in 62%, with 21% being greater than 5 times ULN; elevations correlated with disease severity and its risk factors, male sex, older age, higher BMI and diabetes).
Horby P, Mafham M, Linsell L, Bell JL, Staplin N, Emberson JR, Wiselka M, et al., RECOVERY Collaborative Group. (2020). Effect of hydroxychloroquine in hospitalized patients with Covid-19. N Engl J Med. (Among 1561 patients randomized to receive hydroxychloroquine vs 3155 randomized to standard care, the mortality rate was similar in the two groups [27% vs 25%] but the duration of hospitalization was longer with hydroxychloroquine [16 vs 13 days], while cardiovascular toxicity was not increased with the active drug, there was no mention of ALT elevations or hepatotoxicity).
RECOVERY Collaborative Group. (2020). Lopinavir-ritonavir in patients admitted to hospital with COVID-19 (RECOVERY): a randomised, controlled, open-label, platform trial. Lancet. (Among 5040 adults hospitalized with COVID-19, treatment with lopinavir/ritonavir [400/100 mg once daily for ten days] had no effect on 28-day mortality rate in comparison to controls [23% vs 22%], duration of hospitalization [11 days vs 11 days] or risk of progressing to mechanical ventilation; one serious adverse event occurred that was attributed to lopinavir/ritonavir – an ALT elevation without jaundice that resolved upon stopping).
Marjot T, Moon AM, Cook JA, Abd-Elsalam S, Aloman C, Armstrong MJ, Pose E, et al. (2021). Outcomes following SARS-CoV-2 infection in patients with chronic liver disease: An international registry study. J Hepatol. (Among 745 patients enrolled in an international registry of patients with preexisting chronic liver disease who developed SARS-CoV-2 infection, the mortality rate was 32% in 386 with cirrhosis, increasing with Child’s-Pugh stages [A 19%, B 35%, C 51%], compared to 8% in 359 without cirrhosis, and 2% in a control group without liver disease; patients with cirrhosis often had acute hepatic decompensation [46%] compared to only 1% in those without cirrhosis; the causes of the 123 deaths in patients with cirrhosis were respiratory failure in 71% and liver failure in 19%).
Melquist S, Estepp K, Aleksandrovich Y, Lee A, Beiseker A, Hamedani FS, Bassett J. (2020). COVID-19 presenting as fulminant hepatic failure: A case report. Medicine (Baltimore). (35 year old woman with SLE previously on hydroxychloroquine and mycophenolate, having stopped because of pregnancy and breast feeding, developed COVID-19 infection with mild cough and acute liver failure [ALT 278 U/L Alk P 200 U/L, bilirubin 7.0 mg/dL, INR 1.5 rising to 4.9] accompanied by hepatic encephalopathy, but then improved after restarting hydroxychloroquine and methylprednisolone).
Satarker S, Tom AA, Shaji RA, Alosious A, Luvis M, Nampoothiri M. (2021). JAK-STAT pathway inhibition and their implications in COVID-19 therapy. Postgrad Med. (Review of the mechanism of action and pleomorphic activities of Janus kinase inhibitors and their possible role in treating severe COVID-19 infection which is often accompanied by high levels of proinflammatory cytokines [cytokine storm] with listing of ongoing trials).
Kalil AC, Patterson TF, Mehta AK, Tomashek KM, Wolfe CR, Ghazaryan V, Marconi VC, et al., ACTT-2 Study Group Members. (2021). Baricitinib plus remdesivir for hospitalized adults with Covid-19. N Engl J Med. (Among 1033 patients hospitalized with COVID-19 pneumonia treated with remdesivir in combination with either baricitinib or placebo for up to 14 days, the median time to recovery was faster with baricitinib than placebo [6 vs 7 days] and adverse event rates were lower, serum aminotransferase elevations arising in 1.8% vs 3.1% and to above 5 times ULN in only one baricitinib treated patient).
Hamulka J, Jeruszka-Bielak M, Górnicka M, Drywień ME, Zielinska-Pukos MA. (2020). Dietary supplements during COVID-19 outbreak. Results of Google trends analysis supported by PLifeCOVID-19 online studies. Nutrients. (Analysis of Google searches and online studies during 2020 and the SARS-CoV-2 pandemic found an increased interest in and accompanying use of several dietary supplements including vitamin C, vitamin D, zinc, omega 3 fatty acids, garlic and turmeric despite the fact that none has been shown to help prevent or treat COVID-19).
Calabrese LH, Calabrese C. (2021). Baricitinib and dexamethasone for hospitalized patients with COVID-19. Cleve Clin J Med. (Commentary on the controlled trials of remdesivir, dexamethasone and baricitinib for moderate-to-severe COVID-19 pneumonia mentions that the observed effects of baricitinib when combined with remdesivir have been modest [a one day shortening of recovery time], and there have been no trials comparing baricitinib and dexamethasone which appears to have a major effect on outcome of severe COVID-19 pneumonia).
RECOVERY Collaborative Group. (2021). Azithromycin in patients admitted to hospital with COVID-19 (RECOVERY): a randomised, controlled, open-label, platform trial. Lancet. (Among 2582 hospitalized patients with COVID-19 pneumonia randomized to receive azithromycin [500 mg daily for 10 days] vs 5181 given usual care, the mortality rate in the two groups was identical [22%] and duration of hospitalization similar [10 vs 11 days]; only one serious adverse event was reported due to azithromycin: a self-limited case of pseudomembranous colitis).
PRINCIPLE Trial Collaborative Group. (2021). Azithromycin for community treatment of suspected COVID-19 in people at increased risk of an adverse clinical course in the UK (PRINCIPLE): a randomised, controlled, open-label, adaptive platform trial. Lancet. (In an adaptive UK-based study with a randomized trial of azithromycin [500 mg daily for 3 days] or usual care in patients with suspected COVID-19 who were above the age of 65 years [or above the age of 50 with comorbidities], the rates of recovery by 28 days were similar in the two groups [80% vs 77%], and there were no deaths and few adverse events that could be related to azithromycin).
Marjot T, Webb GJ, Barritt AS, Moon AM, Stamataki Z, Wong VW, Barnes E. (2021). COVID-19 and liver disease: mechanistic and clinical perspectives. Nat Rev Gastroenterol Hepatol. (Review of the hepatotrophism of SARS-CoV-2, the frequency and nature of liver injury in patients with COVID-19, and the excess morbidity and mortality of COVID-19 in patients with preexisting liver disease, cirrhosis or liver transplant).
Solaymani-Dodaran M, Ghanei M, Bagheri M, Qazvini A, Vahedi E, Hassan Saadat S, Amin Setarehdan S, et al. (2021). Safety and efficacy of favipiravir in moderate to severe SARS-CoV-2 pneumonia. Int Immunopharmacol. (Among 373 adults hospitalized with COVID-19 pneumonia treated with favipiravir or lopinavir/ritonavir for 7 days combined with standard care [hydroxychloroquine], the duration of hospitalization [7 vs 6 days], need for ICU care [16% vs 14%] and 28 day mortality [14% vs 12%] were the same in the two groups; no mention of ALT elevations or hepatotoxicity).
Axfors C, Schmitt AM, Janiaud P, Van't Hooft J, Abd-Elsalam S, Abdo EF, Abella BS, et al. (2021). Mortality outcomes with hydroxychloroquine and chloroquine in COVID-19 from an international collaborative meta-analysis of randomized trials. Nat Commun. (In a metaanalysis of 14 published and 14 unpublished clinical trials, including 26 of hydroxychloroquine [10,319 patients] and 4 of chloroquine [307 patients] as therapy of COVID-19, hydroxychloroquine was associated with an excess mortality and chloroquine with no benefit; there was no separate analysis of adverse events).
Pan H, Peto R, Henao-Restrepo AM, Preziosi MP, Sathiyamoorthy V, Abdool Karim Q, Alejandria MM, et al., WHO Solidarity Trial Consortium. (2021). Repurposed antiviral drugs for Covid-19 – interim WHO Solidarity Trial results. N Engl J Med. (Among 11,300 hospitalized adults with COVID-19 enrolled in randomized controlled trials of four repurposed drugs vs standard of care, none of the 4 agents resulted in reduced mortality rates compared to controls: remdesivir 11% versus 11.2%; hydroxychloroquine 11% vs 9.3%; lopinavir/ritonavir 10.6% vs 10.6%; and interferon beta 11.9% vs 10.5%; and there were no deaths attributed to hepatic disease).
Schultz NH, Sørvoll IH, Michelsen AE, Munthe LA, Lund-Johansen F, Ahlen MT, Wiedmann M, et al. (2021). Thrombosis and thrombocytopenia after ChAdOx1 nCoV-19 vaccination. N Engl J Med. (Description of 5 health care workers [4 women, 1 man; ages 32 to 54 years] who developed thromboses in unusual sites [brain, splanchnic bed] and thrombocytopenia 7-10 days after receipt of initial dose of ChAdOx1 vaccine [Astra-Zeneca], all of whom had high levels of antibodies to platelet factor 4 [PF4]- polyanion complexes, 3 of whom died, others seeming to respond to IVIG and prednisolone, referring to the syndrome as vaccine induced thrombotic thrombocytopenia [VITT]).
Greinacher A, Thiele T, Warkentin TE, Weisser K, Kyrle PA, Eichinger S. (2021). Thrombotic thrombocytopenia after ChAdOx1 nCov-19 vaccination. N Engl J Med. (Description of 11 patients [9 women, 2 men, ages 22 to 49 years] who developed thrombotic events in unusual sites [9 cerebral, 3 splanchnic] with symptomatic presentation 5-16 days after an initial dose of ChAdOx1 COVID-19 vaccine, 6 of whom died due to cerebral complications, all having antibodies to platelet factor 4 [PF4]-polyanion complexes independent of heparin and with evidence of platelet activation and thrombocytopenia; patient one developed portal vein thrombosis and had elevations in serum ALT [peak 167 U/L], GGT [110 U/L] and LDH [337 U/L], but bilirubin not reported).
Cines DB, Bussel JB. (2021). SARS-CoV-2 vaccine-induced immune thrombotic thrombocytopenia. N Engl J Med. (Editorial in response to Schultz [2021] and Greinacher [2021] summarizing the clinical and laboratory features, possible pathogenesis and management of vaccine-induced thrombotic thrombocytopenia [VITT] apparently triggered by receipt of adenovirus-based COVID-19 vaccines).
Kumar A, Dowling WE, Román RG, Chaudhari A, Gurry C, Le TT, Tollefson S, et al. (2021). Status report on COVID-19 vaccines development. Curr Infect Dis Rep. (Review of the status of COVID-19 vaccines, over 300 of which are under development and at least 6 approved for emergency use including mRNA-based candidates [7 in clinical trials and 2 approved], DNA based [6 being tested], protein-based [at least 20 in clinical trials but none approved as yet], and viral vector-based [15 in clinical trials and 4 approved]).
(2021). An EUA for sotrovimab for treatment of COVID-19. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy and safety of sotrovimab shortly after its approval for treatment of outpatients diagnosed with COVID-19 who were at high risk for complications, mentions mild complications of rash [2%] and diarrhea [1%], but does not mention ALT elevations or hepatotoxicity).
(2022). Monoclonal antibodies to COVID-19. Med Lett Drugs Ther. (Concise report that the monoclonal antibody combinations of casirivimab with imdevirmab [REGEN-COV] and bamlanivimab with etesevimab have little activity against the Omicron variant of SARS-CoV-2 and should not be used, the only monoclonal antibody with activity against the currently predominant virus being sotrovimab).
Gottlieb RL, Vaca CE, Paredes R, Mera J, Webb BJ, Perez G, Oguchi G, et al. (2022). GS-US-540-9012 (PINETREE) Investigators. Early remdesivir to prevent progression to severe Covid-19 in outpatients. N Engl J Med. (Among 562 non-hospitalized adults with symptomatic COVID-19 and at high risk for complications who were treated with remdesivir [200 mg day 1, 100 mg days 2 and 3] or placebo intravenously once daily, subsequent hospitalization for COVID 19 occurred in 2 remdesivir- vs 15 placebo-treated participants [0.7% vs 5.3%: 87% decline] and none died by day 28; while overall adverse event rates were similar in the 2 arms, the remdesivir treated patients had fewer severe adverse events; no mention of ALT elevations or hepatotoxicity).
(2022). COVID-19 updates. Med Lett Drugs Ther. (Concise review of EUA of remdesivir for prevention of progression of COVID-19 in outpatient adults and children [12 years or above] with symptomatic SARS-CoV-2 infection and who are within 7 days of onset and at high risk of complications; mentions that hypersensitivity reactions can occur, but does not mention ALT elevations or hepatotoxicity).